# Irbesartan

## OVERVIEW

### Introduction

Irbesartan is an angiotensin II receptor blocker used alone or in combination with other agents in the therapy of hypertension and diabetic nephropathy. Irbesartan is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Irbesartan (ir" be sar' tan) was the third angiotensin II receptor blocker (ARB) to be approved for use in the United States and is still widely used for therapy of hypertension. Irbesartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II and which accounts of its antihypertensive activity. Irbesartan was approved for use in the United States in 1997 for hypertension and indications were subsequently expanded to include diabetic nephropathy. Ibresartan is available in 75, 150 and 300 mg tablets generically and under the trade name Avapro. Fixed combinations of irbesartan with hydrochorothiazide are also available (Avalide and others). The typical dose of irbesartan in adults in 150 or 300 mg once daily, and it is used long term. Irbesartan is also available in fixed combinations with hydrochlorothiazide (Avalide). Side effects are uncommon, but can include headache, dizziness, fatigue, cough and gastrointestinal upset. Many ARBs, but not specifically ibresartan, have been implicated in rare instances of a severe sprue-like enteropathy that presents with chronic diarrhea and weight loss with villous flattening and atrophy on intestinal biopsy. This syndrome does not improve to corticosteroids or to a gluetn-free diet, but does resolve promptly with stopping the angiotensin receptor blocker. This side effect is most common with olmesartan.

### Hepatotoxicity

Irbesartan has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported in associated with irbesartan therapy. The onset is usually within 1 to 8 weeks of starting therapy and the serum enzyme pattern is typically hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but irbesartan therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation. Serum aminotransferase levels may also be raised during ARB therapy due to fatty liver and steatohepatitis in patients who develop the severe ARB-related enteropathy.

Likelihood score: C (Probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations and the acute liver injury associated with irbesartan is not known, but resembles idiosyncratic liver injury due to a hypersensitivity reaction. Irbesartan is metabolized by the liver via the cytochrome P450 system, predominantly by CYP 2C9.

### Outcome and Management

The instances of acute liver injury reported with irbesartan use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with irbesartan induced acute liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of irbesartan are given in the Overview section on the angiotensin II receptor antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Candesartan, Eprosartan, Losartan, Olmesartan, Telmisartan, Valsartan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Irbesartan – Avapro®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Irbesartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Irbesartan | 138402-11-6 | C25-H28-N6-O | Chemical Structure for Irbesartan

## OTHER REFERENCE LINKS

1. Recent References on Irbesartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Irbesartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Irbesartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Irbesartan)